# Buchu

## OVERVIEW

### Introduction

Buchu is an herbal product made from a group of aromatic herbs native to South Africa, the leaves of which were used in traditional Khio-San medicine to treat a variety of conditions and are currently used as buchu tea and as dried extracts. Buchu preparations have not been linked to instances of serum enzyme elevations or clinically apparent liver injury with jaundice.

### Background

Buchu (boe’ shoe) is a group of aromatic small shrubs native to South Africa that were used in traditional medicine of the San and Khoikhoi people to treat wounds, stomach complaints, arthritis, and bladder and bowel ailments. Buchu refers specifically to two species in the genus Agathosma (meaning “good fragrance”) that were used in San-Khoi traditional medicine: Agathosma betulina (round or short leaf buchu) and Agathosma crenulata (oval or long leaf buchu). Currently, the aromatic oils of these herbs are used in food preparation as flavoring and in manufacture of perfumes. Dried buchu leaves have been used for medicinal purposes in tonics and as tablets or powders to treat musculoskeletal pain, chronic arthritis, dyspepsia, edema, fever, the common cold, ulcers, irritable bowel syndrome, gout, prostatitis, prostatic hypertrophy, gout and sexually transmitted diseases. However, the efficacy of buchu has not been proven in prospective clinical trials for any of these conditions. More than 120 compounds have been identified in buchu including volatile oils, diospheol, mentone, isomethone, limonine, and pulegone, which is a suspected hepatotoxin. The active ingredients responsible for the purported medicinal effects of buchu are unknown. Laboratory studies of buchu and isolated constituents in cell culture and animal models suggest that it has antimicrobial, antioxidant, antiinflammatory and diuretic properties. However, these properties have not been convincingly shown in human trials. Buchu is most frequently used in teas, the recommended regimen being one cup three times daily. Buchu is generally well tolerated without adverse events; minor side effects may include gastrointestinal upset and urinary tract irritation.

### Hepatotoxicity

Buchu has not been subjected to prospective controlled trials of safety and efficacy but is widely described as being well tolerated and without significant side effects. A single case report of acute hepatitis in a patient taking both buchu and rooibos herbal tea has been published. The patient was also taking an unknown statin, and the contribution of buchu tea to the hepatic injury can only be said to be possible (Case 1). Thus, there is little evidence that buchu in low oral doses or as herbal tea causes clinically apparent liver injury in humans.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

Buchu contains many compounds including pulegone which causes liver injury in rodent models and induces cytotoxicity in cell culture systems. The concentration of pulegone is higher in leaves from Agathosma crenulata than in those of Agathosma betulina. Large oral doses have been found to deplete glutathione, which may the mechanism of its toxic effects.

### Outcome and Management

Hepatotoxicity from buchu must be quite rare if it occurs at all. In the presence of liver injury, stopping use of buchu promptly, even when used as an herbal tea, is warranted.

Drug Class: Herbal and Dietary Supplements

Other names: Boegoe, Bucco, Bookoo, Diosma.

## CASE REPORT

### Case 1. Acute hepatocellular jaundice attributed to herbal teas .(1)

A 52 year old man developed jaundice one month after starting buchu and rooibos herbal tea. He had no history of liver disease or alcohol abuse and no risk factors for viral hepatitis. He had a history of hyperlipidemia and chronic kidney disease due to IgA nephropathy. His medications included oral steroids and long term statin use. On presentation he was jaundiced, but physical examination was otherwise unremarkable. Laboratory testing showed a total bilirubin of 12.1 mg/dL, 8.3 mg/dL direct, with ALT of 2589 U/L, AST1438 U/L and alkaline phosphatase 359 U/L. The INR and platelet count were normal. Testing for hepatitis A, B, C and E as well as for EBV, CMV, HIV and VZV infection were negative, and ANA, SMA and AMA were not detected. An abdominal ultrasound showed a normal appearing liver and no ascites. A liver biopsy revealed mild portal inflammation, spotty necrosis and centrolobular cholestasis without evidence of biliary obstruction. The herbal teas were discontinued and he recovered promptly.

#### Key Points

Medication: | Buchu and Rooibos tea consumption
Pattern: | Hepatocellular [R ~ 22]
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 month
Recovery: | Improved 2 weeks after discharge
Other medications: | “Statin”, “Steroids”

#### Comment

This was the first and the only published report of clinically apparent liver injury attributed to buchu tea. The onset and course were typical of herbal-induced liver injury, but contaminants in the herbal teas or other unacknowledged herbal products are other possible explanations for the hepatitis. In addition, the history was compatible with statin-induced liver injury which on rare occasions arises years after initiation of treatment. It was not clear what statin was used and whether it was discontinued. Ten years after this report, it remained the only published case of clinically apparent liver injury possibly related to buchu.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Buchu – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Buchu | 92346-82-2 (https://pubchem.ncbi.nlm.nih.gov/substance/135330363) | Herbal | Not Applicable

## CITED REFERENCE

1 Engels M, Wang C, Matoso A, Maidan E, Wands J. (2013). Tea not tincture: hepatotoxicity associated with rooibos herbal tea. ACG Case Rep J.

## ANNOTATED BIBLIOGRAPHY

References updated: 03 March 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not buchu).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of buchu).
Simpson D. (1998). Buchu--South Africa's amazing herbal remedy. Scott Med J. (Description of buchu as an herb native to the Cape Province of South Africa which was a traditional medicine used by the San [Bushmen] and Khoikhoi [Hottentot] people who introduced the herb to early Dutch settlers, it being subsequently introduced into Europe and used to treat wounds, stomach ailments, arthritis and diseases of the bladder, the active ingredient being a volatile oil with a peppermint-like odor which has also been used as a flavoring and in perfumes).
Moolla A, Viljoen AM. (2008). 'Buchu' -Agathosma betulina and Agathosma crenulata (Rutaceae): a review. J Ethnopharmacol. (Extensive review of the history of development, chemical constituents, pharmacological activities, and data on clinical efficacy and safety of buchu in humans).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (778 spontaneous reports of adverse reactions to herbals to Swedish Registry, no cases were attributed to buchu).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; buchu is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but does not list or mention buchu).
Engels M, Wang C, Matoso A, Maidan E, Wands J. (2013). Tea not tincture: hepatotoxicity associated with rooibos herbal tea. ACG Case Rep J. (52 year old American man developed acute icteric hepatitis one month after starting a buchu and rooibos herbal tea [bilirubin 12.1 mg/dL, ALT 2589 U/L, Alk P 359 U/L, INR normal], resolving rapidly after stopping the teas on no therapy: Case 1).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention buchu).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to buchu).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal product associated liver injury does not discuss buchu specifically).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss buchu).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of buchu).
Cohen SM, Eisenbrand G, Fukushima S, Gooderham NJ, Guengerich FP, Hecht SS, Rietjens IMCM, et al. (2020). FEMA GRAS assessment of natural flavor complexes: Mint, buchu, dill and caraway derived flavoring ingredients. Food Chem Toxicol. (Formal analysis of the safety of buchu leaves extract used as a flavoring agent in food concluded that it should be generally regarded as safe [GRAS]).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; buchu is not discussed).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; buchu is not mentioned).
Brendler T, Abdel-Tawab M. (2022). Buchu (Agathosma betulina and A. crenulata): rightfully forgotten or underutilized?. Front Pharmacol. (Extensive review of the traditional use of buchu, its taxonomy , biology, introduction into Europe, scientific investigation, phytochemical composition, pharmacological activity, current uses, toxicity and marketing, concluding that recent studies have failed to confirm its purported beneficial effects; mentions that the toxicity found with studies of pulegone used concentrations well above those found in commercially available extracts).

## OTHER REFERENCE LINKS

1 Recent References on Buchu: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Buchu+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Buchu: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Buchu)